# Spironolactone

## OVERVIEW

### Introduction

Spironolactone is an aldosterone receptor antagonist and potassium-sparing diuretic widely used in the therapy of edema, particularly in patients with cirrhosis in which hyperaldosteronism appears to play a major role. Spironolactone has been linked to rare cases of clinically apparent drug induced liver disease.

### Background

Spironolactone (spir on oh lak' tone) is a competitive inhibitor of the mineralocorticoid receptor in the late distal tubule and collecting duct of the kidneys, which causes a decrease in sodium reabsorption and potassium excretion in the distal tubule. As a result, spironolactone promotes a sodium diuresis, but maintains body potassium levels. Spironolactone is particularly helpful in edematous states caused or exacerbated by hyperaldosteronism, which is typical of the edema and ascites caused by cirrhosis. Because of its potassium-sparing actions, spironolactone is also used in combination with thiazide or loop diuretics in an attempt to prevent hypokalemia. Chronic low dose therapy with spironolactone has also been reported to improve survival in patients with heart failure after myocardial infarction. Spironolactone was approved for use in the United States in 1960 and continues to be widely used. Spironolactone is available in 25, 50, 75 and 100 mg tablets generically and under the brand name of Aldactone. Fixed combinations of spironolactone and hydrochlorothiazide are also available under the brand name Aldactizide. The typical dose of spironolactone is 25 mg one to three times daily initially, with modification of the dose based upon clinical efficacy and tolerance to maintenance doses of 75 to 450 mg daily. Spironolactone is usually well tolerated but can cause hyperkalemia and dehydration. In addition, spironolactone has antiandrogen-like effects and can have troublesome side effects of excess and abnormal hair growth and gynecomastia.

### Hepatotoxicity

Clinically apparent liver injury from spironolactone is rare and only a few instances have been reported as isolated case reports. The liver injury typically arises after 4 to 8 weeks of therapy and the pattern of serum enzyme elevations is usually hepatocellular or mixed. Immunoallergic features (rash, fever, eosinophilia) are rare as is autoantibody formation. Recovery has occurred within 1 to 3 months of stopping and all cases have been mild and self-limited in course (Case 1).

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of spironolactone hepatic injury is unknown, but is most likely due to a metabolic idiosyncrasy.

### Outcome and Management

Reported cases of liver injury due to spironolactone have been mild with either no or minimal jaundice, and recovery within a few months of stopping the medication. Recurrence on rechallenge has been reported, but there is no information or cross reactivity to the hepatic injury with other diuretics. Because eplerenone has a similar chemical structure, it is likely to cause a similar hepatic injury.

Drug Class: Diuretics, Potassium-Sparing Diuretics

Other Drugs in the Subclass: Amiloride, Eplerenone, Triamterene

## CASE REPORT

### Case 1. Spironolactone induced liver injury.(1)

A 53 year old woman with primary hyperaldosteronism due to an adrenal adenoma was found to have serum enzyme elevations (ALT 430 U/L, AST 130 U/L, Alk P 225 U/L) without symptoms 1 month after starting spironolactone (100 mg three times daily). Spironolactone was stopped and serum enzymes fell into the normal range within the next two months. One year later, spironolactone was restarted (100 mg twice daily) and serum enzymes were again found to be abnormal one month later. She was not taking other medications and tests for hepatitis B and for autoantibodies were negative. There was no rash, fever or eosinophilia. A liver biopsy showed mild spotty hepatitis. Upon withdrawal of spironolactone, serum enzymes fell to normal within 6 weeks.

#### Key Points

Medication: | Spironolactone (100 mg 2-3 times daily)
Pattern: | Hepatocellular (R=6.7)
Severity: | Mild (enzyme elevations without symptoms or jaundice)
Latency: | 4 weeks
Recovery: | 6-8 weeks
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | GGT (U/L) | Other
Pre | Pre | 15 | 80 | 10
Spironolactone (100 mg three times daily) given for 1 month
4 weeks | 0 | 430 | 185 | 90
6 weeks | 2 weeks | 255 | 225 | 140
8 weeks | 4 weeks | 70 | 150 | 80
12 weeks | 8 weeks | 35 | 105 | 20
24 weeks | 20 weeks | 30 | 90
1 year | 1 year | 25 | 85 | 20
Spironolactone (100 mg two times daily) restarted for 1 month
4 weeks | 0 | 140 | 145 | 45
6 weeks | 2 weeks | 125
10 weeks | 6 weeks | 20 | 80 | 30
Normal Values | | <40 | <110 | < 40

#### Comment

This patient developed elevations in serum aminotransferases and alkaline phosphatase within a month of starting spironolactone. She was evidently asymptomatic and anicteric and the liver injury resolved rapidly upon withdrawal. The rare instances of hepatic injury reported with spironolactone use have been mild and self-limited. The recurrence of injury with the same latency and severity without immunoallergic features suggests metabolic idiosyncrasy as the cause of the hepatotoxicity.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Spironolactone – Generic, Aldactone®

DRUG CLASS

Diuretics

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Spironolactone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Spironolactone | 52-01-7 | C24-H32-O4-S

## CITED REFERENCES

1 Shuck J, Shan S, Owensky L, Leftik M, Cucinell S. (1981). Spironolactone hepatitis in primary hyperaldosteronism. Ann Intern Med.

## ANNOTATED BIBLIOGRAPHY

References updated: 13 October 2021

Zimmerman HJ. Diuretic drugs. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 662-4. (Expert review of hepatotoxicity of diuretics published in 1999 mentions that clinically apparent liver injury due to diuretics is rare; hepatocellular jaundice has been reported with triamterene; no mention of spironolactone).
De Marzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 519-40. (Review of hepatotoxicity of cardiovascular agents, mentions that thiazide diuretics can rarely cause cholestatic hepatitis; no mention of potassium sparing diuretics).
Jackson EK. Drugs affecting renal excretory function. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 445-70. (Textbook of pharmacology and therapeutics).
Shuck J, Shan S, Owensky L, Leftik M, Cucinell S. (1981). Spironolactone hepatitis in primary hyperaldosteronism. Ann Intern Med. (53 year old woman found to have elevations in ALT [430 U/L] and Alk P [225 U/L] 1 month after starting spironolactone, falling to normal in 2 months and rising again [ALT 140 U/L] within 2 months of rechallenge: Case 1, spironolactone).
Renkes P, Gaucher P, Tréchot P. (1995). Spironolactone and hepatic toxicity. JAMA. (74 year old man developed jaundice 7 weeks after starting spironolactone, biopsy showing intrahepatic cholestasis, resolving within 3 months of stopping; no details given).
Thai KE, Sinclair RD. (2001). Spironolactone-induced hepatitis. Australas J Dermatol. (50 year old woman developed fatigue and pruritus 6 weeks after starting spironolactone [bilirubin 2.3 mg/dL, ALT 997 U/L, Alk P 742 U/L], resolving within 3 months of stopping).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 137 [0.5%] were done for idiosyncratic drug induced acute liver failure, none were attributed to a diuretic).
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, García-Ruiz E, García-Muñoz B, et al. (2005). Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish Registry over a 10-year period. Gastroenterology. (Reports of drug induced liver injury to a Spanish network found 570 cases; diuretics not mentioned as cause).
Björnsson E, Olsson R. (2006). Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis. (Survey of drug induced liver fatalities reported to WHO database between 1968-2003 revealed 4690 reports [89% from the US]; no diuretic found in the 20 most commonly implicated agents).
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. (2007). Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther. (Population based survey of 126 cases of acute liver injury [24 with acute liver failure] due to drugs between 1993-1999 in Spain calculated relative risk of injury compared to the general population: hydrochlorothiazide was being taken by 7 and furosemide by 8 patients, but relative risk was not increased in comparison to a control group).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, no case was attributed to a diuretic).
(2009). Drugs for hypertension. Treat Guidel Med Lett. (Brief overview of currently available drugs for hypertension with guidelines on their use and information on prices and toxicities: “thiazide diuretics are the first-line therapy for many patients with hypertension”).
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. (2010). Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol. (Among 313 cases of drug induced liver injury seen over a 12 year period at a large hospital in Bangalore, India, none were attributed to a diuretic).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Among 624,673 adverse event reports in children between 2000 and 2006 in the WHO VigiBase, no diuretic was mentioned among the 30 most common causes of liver injury).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, of which none were attributed to a diuretic).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to a diuretic).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to a diuretic).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to a diuretic).
(2020). Drugs for hypertension. Med Lett Drugs Ther. (Concise summary of efficacy, safety and costs of drug therapy of hypertension including the diuretics, focusing upon relative usefulness; no mention of hepatic adverse events).

## OTHER REFERENCE LINKS

1 Recent References on Spironolactone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Spironolactone/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Spironolactone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Spironolactone)